# Bleomycin

## OVERVIEW

### Introduction

Bleomycin is a cystotoxic antibiotic that is used as an anticancer agent in the therapy of testicular and germ cell cancers, Hodgkin disease, lymphomas and tumors of the head and neck. Therapy with bleomycin in combination with other agents is often associated with mild-to-moderate serum enzyme elevations, but is a rare cause of clinically apparent liver injury.

### Background

The bleomycins are a group of glycopeptide antibiotics that were initially derived from Streptomyces verticillus and later found to have antitumor activity in vitro and in vivo. Bleomycin (blee” oh mye’ sin) is actually a mixture of water soluble glycopeptides that have similar chemical structures and metabolic activities. The cytotoxic effects of bleomycin appear to be due to oxidative damage to DNA, leading to single and double stranded breaks. Bleomycin is concentrated in skin and lung tissue and has significant cutaneous and pulmonary toxicity, but has only mild myelo- and immunosuppressive activities which allows it to be added to regimens that are otherwise limited by these toxicities. Bleomycin was approved for use in the United States in 1973 and current formal indications include testicular and ovarian germ cell tumors, head and neck cancers, Hodgkin and non-Hodgkin lymphomas and malignant pleural effusions. It is usually given in combination with other anticancer agents, most frequently with cisplatin, vinblastine, etoposide, adriamycin or dacarbazine. Bleomycin is available as a solution or lyophilized powder for injection in vials of varying concentrations generically and under the commercial name Blenoxane. The typical dose of bleomycin varies by indication and is adjusted for body weight and renal function. Bleomycin can be given intravenously, intramuscularly or subcutaneously, or instilled into the pleural space for malignant pleural effusions or into the bladder as local treatment for bladder cancer. Common side effects of bleomycin include nausea, diarrhea, headache, dizziness, alopecia, fatigue and weakness. Uncommon, but serious toxicities of bleomycin include interstitial pneumonitis, hypersensitivity reactions and malignant hyperthermia that can be fatal.

### Hepatotoxicity

Chemotherapy with bleomycin in combination with other agents is associated with serum enzyme elevations in 10% to 40% of patients and with levels above 5 times ULN in 1% to 7% of patients, depending upon the dose and other agents used. The ALT elevations are usually asymptomatic and transient, resolving within a month of stopping chemotherapy. In many instances, it is difficult to attribute the liver test abnormalities to bleomycin because of the exposure to other potentially hepatotoxic agents. Rare instances of clinically apparent liver injury have been reported in patients receiving bleomycin, but the time to onset and pattern of injury has varied greatly and was usually attributed to other causes such as reactivation of hepatitis B or to sinusoidal obstruction syndrome due to other alkylating agents. Vanishing bile duct syndrome has been described during chemotherapy of Hodgkin disease with bleomycin containing regimens, but this distinctive form of liver injury also occurs in Hodgkin disease patients who are not treated; some instances arising before the diagnosis of lymphoma. The liver histology of bleomycin hepatotoxicity has not been well characterized, but it causes hepatic steatosis in animal models. In a single case report, biliary strictures and a sclerosing cholangitis-like syndrome was described arising several years after intra-arterial embolization of a large hepatic hemangioma with bleomycin.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bleomycin might cause liver injury is not known. Bleomycin is generally cytotoxic, and the minor serum enzyme elevations that occur during therapy are likely due to a direct toxic effect on hepatocytes. Bleomycin is not concentrated in the liver and has minimal hepatic metabolism.

### Outcome and Management

The hepatic injury caused by bleomycin is usually mild, asymptomatic and rapidly reversible. Chemotherapeutic regimens that include bleomycin have been implicated in causing reactivation of hepatitis B and sinusoidal obstruction syndrome, but bleomycin has not been specifically implicated in these forms of liver injury. There is no evidence of cross sensitivity to liver injury between bleomycin and other antineoplastic agents, including the antibiotics such as dactinomycin, doxorubicin or mithramycin.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Mitoxantrone, Plicamycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bleomycin – Blenoxane®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bleomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bleomycin | 11056-06-7 | C55-H84-N20-O21-S2.C55-H84-N17-O21-S3 | Bleomycin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 September 2017

Zimmerman HJ. Antibiotics. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 694-8. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that bleomycin causes steatosis in animals, but that hepatotoxicity in humans is usually overshadowed by other organ injury and has not been well characterized).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; bleomycin is not discussed).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Antibiotics. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1712-5. (Textbook of pharmacology and therapeutics).
Umezawa H, Ishizuka M, Maeda K, Takeuchi T. Studies on bleomycin. Cancer 1967; 20: 891-5. (Studies of anticancer activity of bleomycin in cell culture and animal models, showing transient liver injury in dogs and concentration of drug in skin and lungs). 5337399
Huntington MC, DuPriest RW, Fletcher WS. Intra-arterial bleomycin therapy in inoperable squamous cell carcinomas. Cancer 1973; 31: 153-8. (Among 21 patients with various forms of advanced squamous cell cancer treated with intraarterial bleomycin, one had mild liver toxicity, with transient rise in AST and Alk P). 4118911
Blum RH, Carter SK, Agre K. A clinical review of bleomycin--a new antineoplastic agent. Cancer 1973; 31: 903-14. (Summary of safety and efficacy of bleomycin based upon clinical trials in 1174 patients with various solid tumors and lymphomas; side effects included mucositis [20-38%], pyrexia [26-50%], nausea [14-42%], alopecia [13-41%], and pulmonary toxicity [9-12%], whereas bone marrow and liver toxicity were uncommon). 4122362
Hubbard SP, Chabner BA, Canellos GP, Young RC, DeVita VT Jr. High dose intravenous bleomycin in the treatment of advanced lymphomas. Eur J Cancer 1975; 11: 623-6. (Among 22 patients with advanced lymphoma receiving 5 day courses of high dose bleomycin, two had liver toxicity, one with jaundice, both resolving within a week of stopping, recurring with repeat courses in one but not the other patient). 56271
Ichikawa T. Discovery of clinical effect of bleomycin and its further development. Prog Biochem Pharmacol 1976; 11: 143-57. (History of development of bleomycin as an anticancer agent in humans, with success in early experience in penile cancer; common side effects were pyrexia, anorexia, nausea, headache, alopecia and fatigue; no mention of hepatotoxicity). 63959
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987: 237-56. (Overview of hepatotoxicity of antineoplastic agents; "Although a few cases of transient hepatic dysfunction have been reported during bleomycin administration, these have not been ascribed specifically to the drug"). 3317861
Faggioli P, De Paschale M, Tocci A, Luoni M, Fava S, De Paoli A, Tosi A, Cassi E. Acute hepatic toxicity during cyclic chemotherapy in non Hodgkin's lymphoma. Haematologica 1997; 82: 38-42. (Among 98 patients with non-Hodgkin lymphoma treated with various chemotherapeutic regimens [some of which included bleomycin], 20 had transient ALT elevations and 12 acute hepatitis, 8 of whom were HBsAg positive and frequently had evidence of reactivation). 9107080
Avilés A, Guzmán R, Talavera A, García EL, Díaz-Maqueo JC. Randomized study for the treatment of adult advanced Hodgkin's disease: epirubicin, vinblastine, bleomycin, and dacarbazine (EVBD) versus mitoxantrone, vinblastine, bleomycin, and dacarbazine (MVBD). Med Pediatr Oncol 1994; 22: 168-72. (Among 70 patients with advanced Hodgkin disease treated with epirubicin or mitoxantrone combined with bleomycin-vinblastine-dacarbazine [BVD], 6 receiving mitoxantrone, but none epirubicin, developed hepatotoxicity [AST, Alk P or bilirubin above 3 times ULN]). 7505877
Soh LT, Ang PT, Sng I, Chua EJ, Ong YW. Fulminant hepatic failure in non-Hodgkin lymphoma patients treated with chemotherapy. Eur J Cancer 1992; 28A (8-9): 1338-9. (Four patients with non-Hodgkin lymphoma and HBsAg developed fatal acute hepatitis after several courses of combination chemotherapy [3 received methotrexate, doxorubicin, cyclophosphamide, vincristine, bleomycin and prednisone], attributed to reactivation of hepatitis B). 1381211
Fisher RI, Gaynor ER, Dahlberg S, Oken MM, Grogan TM, Mize EM, Glick JH, et al. Comparison of a standard regimen (CHOP) with three intensive chemotherapy regimens for advanced non-Hodgkin's lymphoma. N Engl J Med 1993; 328: 1002-6. (Controlled trial of CHOP vs 3 different complex anticancer regimens that included bleomycin in 1138 patients with non-Hodgkin lymphoma found similar efficacy, but fewer severe side effects with conventional CHOP therapy; hepatotoxicity was not mentioned and severe toxicities were attributed largely to granulocytopenia and infections). 7680764
Sertoli MR, Santini G, Chisesi T, Congiu AM, Rubagotti A, Contu A, Salvagno L, et al. MACOP-B versus ProMACE-MOPP in the treatment of advanced diffuse non-Hodgkin's lymphoma: results of a prospective randomized trial by the non-Hodgkin's Lymphoma Cooperative Study Group. J Clin Oncol 1994; 12: 1366-74. (Controlled trial of two anticancer regimens [one with bleomycin] in 221 patients with non-Hodgkin lymphoma, found similar rates of efficacy and safety; liver test abnormalities occurred in 37%, and were above 5 times ULN in 7% of patients receiving MACOP-bleomycin compared to 19% and 2% on ProMACE-MOPP). 7517442
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to bleomycin). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none to bleomycin). 20949552
Wong KM, Chang CS, Wu CC, Yin HL. Hodgkin's lymphoma-related vanishing bile duct syndrome: a case report and literature review. Kaohsiung J Med Sci 2013; 29: 636-41. (A 38 year old man presented with jaundice and was found to have Hodgkin disease and paucity of intrahepatic bile ducts [bilirubin 14.8 mg/dL, ALT 181 U/L, Alk P 155 U/L] and responded to chemotherapy with doxorubicin, bleomycin, vinblastine and dacarbazine followed by hematopoietic cell transplantation, with resolution of jaundice and improvement in liver histology and appearance of bile ducts). 24183359
Aleem A, Al-Katari M, Alsaleh K, AlSwat K, Al-Sheikh A. Vanishing bile duct syndrome in a Hodgkin's lymphoma patient with fatal outcome despite lymphoma remission. Saudi J Gastroenterol 2013; 19: 286-9. (33 year old man presented with jaundice and lymphoadenopathy and was found to have Hodgkin disease [bilirubin 5.1 mg/dL, ALT 194 U/L, Alk P 524 U/L], with worsening after chemotherapy with doxorubicin, bleomycin, vinblastine and dacarbazine [bilirubin rise to 35 mg/dL] and progressive liver failure, leading to death despite remission in Hodgkin disease). 24195983
Hallén K, Sangfelt P, Nilsson T, Nordgren H, Wanders A, Molin D. Vanishing bile duct-like syndrome in a patient with Hodgkin lymphoma - pathological development and restitution. Acta Oncol 2014; 53: 1271-5. (Patient with Crohn disease developed jaundice and intractible pruritus and was found to have Hodgkin disease which was treated with bleomycin-based regimen and rituximab, biopsy showing cholestasis and bile duct loss, but with subsequent improvement of the liver condition starting 5 months after chemotherapy, ultimately with normal liver tests). 24697745
Thakar K, Novero A, Das A, Lisinschi A, Mehta B, Ahmed T, Liu D. CEPP regimen (cyclophosphamide, etoposide, procarbazine and prednisone) as initial treatment for Hodgkin lymphoma patients presenting with severe abnormal liver function. Biomark Res 2014; 2: 12. (Two men, ages 38 and 49 presented with liver injury [bilirubin 14.5 and 2.5 mg/Dl, ALT 486 and 312 U/L, Alk P 183 and 181 U/L], subsequently developing fever and pancytopenia and diagnosis of Hodgkin disease, both responding to CEPP regimens with improvement in lymphoma and in liver injury). 24991411
Yeh P, Lokan J, Anantharajah A, Grigg A. Vanishing bile duct syndrome and immunodeficiency preceding the diagnosis of Hodgkin lymphoma. Intern Med J 2014; 44: 1240-4. (75 year old man developed jaundice and vanishing bile duct syndrome of uncertain cause that slowly resolved clinically, but with persistent Alk P and GGT elevations and presentation with Hodgkin lymphoma 18 months later, eventually dying of end stage liver disease). 25442758
Jin S, Shi XJ, Sun XD, Wang SY, Wang GY. Sclerosing cholangitis secondary to bleomycin-iodinated embolization for liver hemangioma. World J Gastroenterol 2014; 20: 17680-5. (44 year old woman presented with jaundice and abdominal pain and severe biliary strictures requiring right lobectomy and hepato-jejunostomy, 6 years after transarterial chemo-embolization of a large hepatic hemangioma using bleomycin). 25516686
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to antineoplastic agents, but none were attributed to bleomycin). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Bleomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bleomycin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bleomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bleomycin)